# Lion’s Mane

## OVERVIEW

### Introduction

Lion’s mane, Hericium erinaceus, is an edible mushroom found most abundantly in East Asia that has been used widely as a food and as an herbal medication in traditional Chinese medicine. Recently, lion’s mane has been purported to improve cognition and relieve anxiety and depression. Lion’s mane is generally recognized as safe and has not been linked to serum enzyme elevations during therapy nor to episodes of clinically apparent liver injury.

### Background

Lion’s mane (Hericium erinaceus) is saprophytic mushroom found throughout the Northern hemisphere and used for centuries in traditional Chinese medicine generally as a tonic to relief stress, anxiety and depression. Lion’s mane mushroom typically grows on the trunks of dead hardwood trees and has distinctive long, white dangling spines that resemble as lion’s mane. As a traditional medicine, lion’s mane was purported to have multiple potentially beneficial activities including antioxidant, antidiabetic, antilipidemic, antihypertensive, antineoplastic, an immunomodulatory activities as well as hepatoprotective, neuroprotective and cardiovascular protective properties. Most of these effects have been demonstrated in cell culture or in animal models but have not been found in humans. Chemical analyses demonstrate multiple constituents in Hericium erinaceus including unique hericenones, erinacine terpenoids, beta-polysaccharides, and phenolic acids as well as lectins, proteins, fatty acids, sterols, and multiple minerals and vitamins as are found in multiple mushroom species. Which ingredient is responsible for the purported effects of lion’s mane are unknown. Erinacines have been found to cross the blood-brain barrier in rats and to stimulate synthesis of nerve growth factor, to speed recovery from ischemic injury, and improve alertness and learning in mice. These neuroprotective and mental cognitive enhancing activities have not been shown to any great extent in humans. At present, lion’s mane is not approved for treatment of symptoms or any diseases in humans in the United States. Nevertheless, it is widely available in nutrition centers and on the internet and purported to improve memory and cognitive function. The typical dose in 1 to 3 mg daily. The few studies of short term therapy with lion’s mane in humans reported few adverse events and scant evidence of any toxicity. In clinical trials of prolonged therapy, mild gastrointestinal complains of abdominal discomfort, nausea, or diarrhea have been reported usually in less than 10% of treated subjects and generally not requiring discontinuation of the herbal product. At least one example of an acute hypersensitivity reaction to oral lion’s mane has been described.

### Hepatotoxicity

Lion’s mane has not been subjected to prospective trials of its safety but is widely described as being well tolerated and without side effects. In small clinical trials, there have been no case reports of clinically apparent liver injury attributed to lion’s mane, and it is not mentioned or listed in large case series or systematic reviews of the literature on herbal and dietary supplement induced liver injury. Thus, there is little evidence that lion’s mane in typical oral doses or as a component of herbal products or teas causes clinically apparent liver injury in humans.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Lion’s mane has not been linked to serum enzyme elevations during therapy or clinically apparent liver injury. The mechanism by which lion’s mane might cause liver injury is not known but more than a thousand components have been identified in Hericium erinaceus extracts, some of which are unique to this species of mushroom. The major components responsible for its purported effects include β glucan polysaccharides, hericenones, and erinacine terpenoids.

Drug Class: Herbal and Dietary Supplements

Other names: Hericium erinaceus, hedgehog fungus, monkey head, bearded tooth, satyr’s beard, Yamabushitake, and pom pom.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lion’s Mane – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Erinacine A | 156101-08-5 | C25-H36-O6 | SID: 85374575
L-Ergothioneine | 497-30-3 | C9-H15-N3-O2-S | SID: 134977585

## ANNOTATED BIBLIOGRAPHY

References updated: 05 January 2024

Abbreviations: HDS, herbal and dietary supplements; DILI, drug-induced liver injury; ALS, amyotrophic lateral sclerosis.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not lion’s mane).
Mori K, Inatomi S, Ouchi K, Azumi Y, Tuchida T. Improving effects of the mushroom Yamabushitake (Hericium erinaceus) on mild cognitive impairment: a double-blind placebo-controlled clinical trial. Phytother Res. 2009;23:367-72. (Among 30 Japanese adults [ages 50 to 80 years] with mild cognitive impairment treated with powdered Yamabushitake [Hericium erinaceus: 3 grams daily] or placebo for 16 weeks, dementia symptom scales improved with the H. erinaceus preparation but not with placebo, and side effects were limited to mild abdominal discomfort and diarrhea, while serum ALT, AST, Alk P, and bilirubin levels remained in the normal range). 18844328
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Among 778 spontaneous reports of adverse reactions to herbal and alterative medicines to a national Swedish Registry, no cases were attributed to lion’s mane). 19650152
Nagano M, Shimizu K, Kondo R, Hayashi C, Sato D, Kitagawa K, Ohnuki K. Reduction of depression and anxiety by 4 weeks Hericium erinaceus intake. Biomed Res. 2010;31:231-7. (Among 30 adult Japanese women with “a variety of indefinite complaints and no specified diseases” who received H. erinaceus cookies [2 gm] or similar placebo cookies daily for 4 weeks, there were no differences in changes from baseline between the two groups in menopausal, depression, and sleep scales, but indefinite complaints index scores for “irritating”, “anxious” and “pulpitation” improved with the herbal therapy but not with placebo; no mention of ALT levels or adverse events). 20834180
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention lion’s mane). 22928722
Khan MA, Tania M, Liu R, Rahman MM. Hericium erinaceus: an edible mushroom with medicinal values. J Complement Integr Med. 2013; 10 (1): 253-258. (Review of the purported biologic effects of lion’s mane mushrooms as shown in animal models or in vitro, including antioxidant, antineoplastic, antihypertensive, antidiabetic, hepatoprotective, neuroprotective, cardioprotective, immunomodulatory, wound healing, and lipid lowering properties). 23735479
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury does not mention lion’s mane). 23121117
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies; no mention of lion’s mane). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Rleddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to lion’s mane). 25043597
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss lion’s mane). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish Drug-Induced Liver Injury Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of lion’s mane). 29307848
Saitsu Y, Nishide A, Kikushima K, Shimizu K, Ohnuki K. Improvement of cognitive functions by oral intake of Hericium erinaceus. Biomed Res. 2019;40:125-131. (Among 31 adults above the age of 50 with mild cognitive difficulties who were treated with Hericium erinaceus for 12 weeks, there were no significant differences in changes from baseline in scores of three standard cognitive tests between the two groups; no mention of adverse events or ALT levels). 31413233
Li IC, Chang HH, Lin CH, Chen WP, Lu TH, Lee LY, Chen YW, et al. Prevention of early Alzheimer's disease by erinacine A-enriched Hericium erinaceus mycelia pilot double-blind placebo-controlled study. Front Aging Neurosci. 2020;12:155. (Among 49 Chinese adults with mild Alzheimer’s disease treated with erinacine A enriched Hericium erinaceus [350 mg three times daily] or placebo for 48 weeks, lion’s mane treated subjects had more improvement in cognitive tests than placebo recipients and the only adverse events were abdominal discomfort, nausea, and diarrhea affecting 8% of patients; no mention of ALT levels of hepatotoxicity). 32581767
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; lion’s mane is not listed or discussed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; lion’s mane is not mentioned). 33434654
Grozier CD, Alves VA, Killen LG, Simpson JD, O'Neal EK, Waldman HS. Four weeks of Hericium erinaceus supplementation does not impact markers of metabolic flexibility or cognition. Int J Exerc Sci. 2022;15:1366-1380. (Among 24 college age healthy adults treated with Hericium erinaceus [10 grams daily] or placebo for 4 weeks there were no differences in degree of changes in metabolic flexibility including fat and carbohydrate metabolism nor in cognitive function in the two arms). 36582308
Uffelman CN, Doenges KA, Armstrong ML, Quinn K, Reisdorph RM, Tang M, Krebs NF, et al. Metabolomics profiling of white button, crimini, portabella, lion's mane, maitake, oyster, and shiitake mushrooms using untargeted metabolomics and targeted amino acid analysis. Foods. 2023;12:2985. (Chemical analysis of 7 mushroom species used in traditional medicine found 1344 compounds shared by all 7, but all also had unique ingredients which were more than 800 for lion’s mane which had the highest levels of the amino acid L-ergothioneine among the seven, but concentrations varied considerably among different preparations perhaps reflecting harvesting time and region of cultivation). 37627983
Nieman KM, Zhu Y, Tucker M, Koecher K. The role of dietary ingredients in mental energy - a scoping review of randomized controlled trials. J Am Nutr Assoc. 2023:1-16. (Review of literature on 18 dietary ingredients purported to increase mental energy identified 101 studies [on 16 ingredients] among which lion’s mane, ashwagandha, chamomile, dark chocolate, ginseng, lavender tea, maca, turmeric and valerian were said to be “promising”). 37162192
Hersant H, He S, Maliha P, Grossberg G. Over the counter supplements for memory: a review of available evidence. CNS Drugs. 2023;37:797-817. (Analysis of 103 supplements sold as improving memory identified 18 common ingredients, and a review of controlled trials of these compounds found some evidence for effects of ashwagandha, choline, curami, ginger, lion’s mane, polyphenol, phosphatidylserine, and turmeric, but no compelling evidence for use of coenzyme Q, theanine, omega 3 fatty acids, or vitamins B6, B9 and B12; mentions that more than a billion US dollars are spent on supplements for improving cognition yearly). 37603263
Docherty S, Doughty FL, Smith EF. The acute and chronic effects of lion's mane mushroom supplementation on cognitive function, stress and mood in young adults: a double-blind, parallel groups, pilot study. Nutrients. 2023;15:4842. (Among 41 healthy adults ages 18 to 45 years who were treated with Hericium erinaceus [1.8 grams] or placebo daily for 28 days, speed of performance was improved with an initial dose while chronic therapy led to a reduction in stress, but multiple cognitive function tests were performed and most did not change significantly and some improved with placebo therapy; adverse events were not discussed). 38004235
La Monica MB, Raub B, Ziegenfuss EJ, Hartshorn S, Grdic J, Gustat A, Sandrock J, et al. Acute effects of naturally occurring guayusa tea and Nordic lion's mane extracts on cognitive performance. Nutrients. 2023;15:5018. (Among 40 healthy adults treated with a single dose of H. erinaceus (1 gram), guayusa (650 mg), or placebo, there were minor improvements in cognitive performance within a hour of ingestion of lion’s mane, while no adverse events were reported except for a slight increase in blood pressure with guayusa, which was attributed to its caffeine content which also may have accounted for its effects on cognition). 38140277
Muhanna M, Lund I, Bromberg M, Wicks P, Benatar M, Barnes B, Pierce K, et al. ALS Untangled #73: Lion's mane. Amyotroph Lateral Scler Frontotemporal Degener. 2023 Dec 23:1-4. (Systematic review of the literature of the possible beneficial effects of lion’s mane in amyotrophic lateral sclerosis [ALS] found no studies in ALS relevant cell or animal models and no clinical trials in humans with ALS). 38141002

## OTHER REFERENCE LINKS

Recent References on Lion’s Mane: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lion%E2%80%99s+Mane+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Lion’s Mane: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lion%E2%80%99s%20Mane)